# Silodosin

## OVERVIEW

### Introduction

Silodosin is a selective alpha-1a adrenergic antagonist used in the therapy of benign prostatic hypertrophy. Silodosin is associated with a low rate of serum aminotransferase elevations and to rare instances of clinically apparent acute liver injury.

### Background

Silodosin (sye loe' doe sin) is a selective alpha-1a adrenergic antagonist approved for use in the United States for benign prostatic hypertrophy. Silodosin inhibits alpha adrenergic receptors present on smooth muscle in the bladder neck and prostate (alpha-1a adrenergic receptors). It has minimal effects on alpha-1b adrenergic receptors present in arterioles, which are responsible for the antihypertensive effects of the nonspecific alpha-1 adrenergic blockers. The effects of the agent on smooth muscle of the bladder neck and prostate cause improvement in urine flow in men with partial obstruction due to benign prostatic hypertrophy. Silodosin was approved for use in the United States in 2007 for treatment of symptoms of urinary hesitancy due to benign prostatic hypertrophy. Silodosin is available in capsules of 4 and 8 mg under the trade name Rapaflo. The recommended dose is 4 to 8 mg once daily. Side effects include retrograde ejaculation, orthostatic hypotension, dizziness, diarrhea, thirst, nasal stuffiness and headache. Rare, but potentially severe adverse events include severe postural hypotension and intraoperative floppy iris syndrome

### Hepatotoxicity

Silodosin has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo or comparative agent therapy. These elevations were transient and did not require dose modification. No instances of clinically apparent acute liver injury due to silodosin have been published in the literature, but reports of jaundice with serum enzyme elevations have been received by the sponsor. Among the alpha adrenergic receptor antagonists, the most frequently implicated agent in causing liver injury has been alfuzosin with only single, and not well documented cases linked to other alpha blockers. Thus, acute symptomatic liver injury due to silodosin is quite rare, if it occurs at all.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum aminotransferase elevations and rare instances of acute liver injury associated with the alpha-1a adrenergic antagonists is not known. Silodosin is partially metabolized by the liver by the cytochrome P450 enzymes (predominantly CYP 3A4) and generation of a mildly toxic intermediate is a possible explanation.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been reported in association with the alpha-1 adrenergic blockers. There is no information on cross reactivity of the liver injury among the various adrenergic receptor antagonists, but similarity of chemical structure suggests that cross sensitivity may be present.

References to the safety and potential hepatotoxicity of alfuzosin are given in the Overview on the Alpha-1 Adrenergic Receptor Antagonists.

Drug Class: Benign Prostatic Hypertrophy Agents

Other Drugs in the Class:

- Alpha-1 Adrenergic Receptor Antagonists
  - Alfuzosin, Doxazosin, Tamsulosin, Terazosin
- 5-Alpha Reductase Inhibitors
  - Dutasteride, Finasteride

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Silodosin – Rapaflo®

DRUG CLASS

Benign Prostatic Hypertrophy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=silodosin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Silodosin | 160970-54-7 | C25-H32-F3-N3-O4 | Silodosin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Silodosin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Silodosin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Silodosin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Silodosin)